# Paroxetine

## OVERVIEW

### Introduction

Paroxetine is a selective serotonin reuptake inhibitor (SSRI) used in the therapy of depression, anxiety disorders and obsessive-compulsive disorder. Paroxetine therapy can be associated with transient asymptomatic elevations in serum aminotransferase levels and has been linked to rare instances of clinically apparent acute liver injury.

### Background

Paroxetine (pa rox' e teen) is a selective serotonin reuptake inhibitor (SSRI) that acts by blocking the reuptake of serotonin in CNS synaptic clefts, thus increasing serotonin levels in the brain which is associated with its psychiatric effects. Paroxetine was approved for use in the United States in 1992 and it remains in wide use, with more than 15 million prescriptions being filled yearly. Indications for paroxetine include major depression, obsessive-compulsive disorder, panic disorder, and anxiety disorders including social anxiety, post-trauma stress and generalized anxiety disorder. Paroxetine is also used for headache, premenstrual dysphoric disorder, diabetic neuropathy and premature ejaculation. Paroxetine is available as tablets of 10, 20, 30 and 40 mg and as an oral suspension in generic forms and under the brand names of Paxil and Pexeva. The recommended dosage for depression in adults is 20 mg once daily, increasing the dosage by 10 mg increments weekly to a maximum of 50 mg. Controlled release tablets are also available that have slightly different dosing recommendations. Common side effects are drowsiness, dyspepsia, nausea, headache, increased sweating, increased appetite, weight gain and sexual dysfunction. Rare but potentially severe adverse events include suicidal ideation and behavior, activation of mania, serotonin syndrome, discontinuation syndrome, increased risk of bleeding, seizures, acute glaucoma, hypersensitivity reactions and embryo-fetal toxicity.

### Hepatotoxicity

Liver test abnormalities have been reported to occur in up to 1% of patients on paroxetine, but elevations are usually modest and usually do not require dose modification or discontinuation. Rare instances of acute, clinically apparent episodes of liver injury, with marked liver enzyme elevations with or without jaundice, have been reported in patients on paroxetine. The onset of injury is usually within 2 to 16 weeks, but can be more delayed, to up to 1 year. The pattern of serum enzyme elevations varies from hepatocellular to mixed or cholestatic. While most cases are mild-to-moderate in severity, severe cases with hepatic failure have been reported. Autoimmune (autoantibodies) and immunoallergic features (rash, fever, eosinophilia) are uncommon.

Likelihood score: B (likely but rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which paroxetine causes liver injury is not known. Paroxetine is metabolized at least in part by the liver, mainly via the cytochrome P450 system, and hepatotoxicity may be mediated by toxic intermediates of its metabolism.

### Outcome and Management

The serum aminotransferase elevations that occur on paroxetine therapy are usually self-limited and do not require dose modification or discontinuation of therapy. Acute liver failure has been reported, but is very rare with paroxetine induced liver injury as is chronic liver injury. Persons with intolerance to paroxetine may have similar reactions to other SSRIs and careful monitoring is warranted if other such agents are used.

Drug Class: Antidepressant Agents

Other Drugs in the Subclass, SNRIs/SSRIs: Citalopram, Escitalopram, Duloxetine, Fluoxetine, Fluvoxamine, Levomilnacipran, Sertraline, Venlafaxine, Vilazodone, Vortioxetine

## CASE REPORT

### Case 1. Serum enzyme elevations during paroxetine therapy.(1)

A 64 year old woman with long history of recurrent depression developed liver enzyme elevations 32 days after starting paroxetine. She had a seven year history of episodic depression and had received several courses of various monoamine oxidase inhibitors and tricyclic antidepressants in the past. After failure of these agents for a particularly difficult episode of depression, she was started on paroxetine with regular monitoring and increase of the dosage from 5 to 60 mg per day, along with “lithium augmentation”. Ten days after escalating the dose of paroxetine, she had mild nausea but improved mood. Routine laboratory testing showed elevations in serum enzymes (Table) and paroxetine was stopped. Tests for hepatitis A, B and C were negative as was ultrasonography of the abdomen. Within 14 days, serum enzymes had fallen to normal and she was switched to amitriptyline with continued improvement in depression and no enzyme elevations.

#### Key Points

Medication: | Paroxetine (5 to 60 mg/day)
Pattern: | Hepatocellular (R=7)
Severity: | 1+ (serum enzyme elevations, mild symptoms)
Latency: | 32 days
Recovery: | 14 days
Other medications: | Low doses of lithium (200 mg daily)

#### Laboratory Values

Time After Starting | Time After Stopping | ALT* (U/L) | Alk* P (U/L) | Bilirubin (mg/dL) | Other
- 2 weeks | Pre | 20 | 85 | 0.4
Paroxetine given initially at 5 mg/day and gradually increased to 60 mg/day
4 weeks | 0 | 592 | 226 | 1.7 | Paroxetine=203 ng/mL
| 1 day | 480 | | | Lithium=0.15 mmol/L
| 2 days | 230 | 160
| 3 days | 160 | 155
| 6 days | 75 | 135
| 10 days | 45 | 110
6 weeks | 2 weeks | 25 | 105 | Normal
Normal Values | | <40 | <115 | <1.2

* Estimated from Figure 1.

#### Comment

Convincing report of abnormal serum aminotransferase and alkaline phosphatase levels developing during somewhat high dose paroxetine therapy. The patient had few if any symptoms attributable to the liver injury and did not become jaundiced (although serum bilirubin levels rose slightly). Serum paroxetine levels were high and lithium levels were minimal. There was prompt improvement on stopping therapy. There was no cross sensitivity to tricyclic antidepressants which were subsequently used.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Paroxetine – Generic, Paxil®

DRUG CLASS

Antidepressant Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=paroxetine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Paroxetine | 61869-08-7 | C19-H20-F-N-O3

## CITED REFERENCE

1 Helmchen C, Boerner RJ, Meyendorf R, Hegerl U. (1996). Reversible hepatotoxicity of paroxetine in a patient with major depression. Pharmacopsychiatry.

## ANNOTATED BIBLIOGRAPHY

References updated: 08 April 2020

Abbreviations: MAO inhibitor, monoamine oxidase inhibitor; SSRI, selective serotonin reuptake inhibitor; SNRI, serotonin and norepinephrine reuptake inhibitor.

Zimmerman HJ. Antidepressants. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 493-8. (Expert review of hepatotoxicity published in 1999; mentions one case report of acute and one of chronic drug induced liver injury due to paroxetine).
Larrey D, Ripault MP. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 443-62. (Review of hepatotoxicity of antidepressants mentions that clinically apparent liver injury from the SSRIs is rare but paroxetine is the most frequently implicated, causing a range of clinical presentations of acute hepatitis, usually hepatocellular or mixed).
O'Donnell JM, Bies RR, Shelton RC. Drug therapy of depression and anxiety disorders. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 267-77. (Textbook of pharmacology and therapeutics).
Boyer WF, Blumhardt CL. (1992). The safety profile of paroxetine. J Clin Psychiatry. (Pooled data on 4126 patients on paroxetine, 1811 comparator antidepressants and 625 placebo in clinical trials; there were “no statistically significant changes in hepatic or renal function”; one case of hepatitis possibly related to paroxetine mentioned).
Dunbar GC, Claghorn JL, Kiev A, Rickels K, Smith WT. (1993). A comparison of paroxetine and placebo in depressed patients. Acta Psychiatr Scand. (Pooled analysis of trials of paroxetine [n=167] vs placebo [n=169] for 6 weeks; side effects more common with paroxetine, with nausea, somnolence, sweating, dry mouth and constipation; no laboratory test abnormalities noted).
Helmchen C, Boerner RJ, Meyendorf R, Hegerl U. (1996). Reversible hepatotoxicity of paroxetine in a patient with major depression. Pharmacopsychiatry. (64 year old woman with onset of liver test abnormalities 32 days after starting paroxetine [peak bilirubin 1.7 mg/dL, ALT 592 U/L, Alk P 226 U/L, without eosinophilia], resolving within 2 weeks of stopping: Case 1).
Benbow SJ, Gill G. (1997). Paroxetine and hepatotoxicity. BMJ. (54 year old woman found to have elevated AST [256 U/L] with normal bilirubin and Alk P 10 months after starting paroxetine; 6 months later AST was still elevated [299 U/L] and liver biopsy showed chronic hepatitis; AST fell with stopping paroxetine).
de Man RA. (1997). Ned Tijdschr Geneeskd. (52 year old man with chronic hepatitis B and cirrhosis developed severe flare of hepatitis 10 months after starting paroxetine [bilirubin ~2.6 mg/dL, AST rising to 800 U/L] and appearance of ascites, improving with stopping paroxetine, no information on change of HBV DNA levels).
Mourilhe P, Stokes PE. (1998). Risks and benefits of selective serotonin reuptake inhibitors in the treatment of depression. Drug Saf. (Review of pharmacology, efficacy and safety of SSRIs; no mention of ALT elevations or hepatotoxicity).
Grohmann R, Rüther E, Engel RR, Hippius H. (1999). Assessment of adverse drug reactions in psychiatric inpatients with the AMSP drug safety program: methods and first results for tricyclic antidepressants and SSRI. Pharmacopsychiatry. (Analysis of reporting of adverse events among inpatients in 29 German hospitals between 1993 to 1997; 896 severe adverse events among 48,564 patients [1.8%], both total and hepatic events were more common with tricyclics than SSRIs).
Cadranel JF, DiMartino V, Cazier A, Pras V, Bachmeyer C, Olympio P, Gonzenbach A, et al. (1999). Atrium and paroxetine-related severe hepatitis. J Clin Gastroenterol. (Two cases; 31 and 35 year old women developed hepatitis 4 and 15 months after starting “Atrium” and paroxetine [bilirubin 11.6 and 5.8 mg/dL, ALT 2010 and 539 U/L, Alk P 86 and 243 U/L], resolving within 3 and 6 months of stopping both drugs; paroxetine may have predisposed to Atrium hepatotoxicity).
Odeh M, Misselevech I, Boss JH, Oliven A. (2001). Severe hepatotoxicity with jaundice associated with paroxetine. Am J Gastroenterol. (49 year old man with ulcerative colitis on 5-aminosalicyclic acid [a-ASA] developed jaundice and pruritus 6 weeks after starting paroxetine [bilirubin 10.1 mg/dL, ALT 561 U/L, Alk P 455 U/L], resolving within 10 weeks of stopping despite restarting 5-ASA).
Azaz-Livshits T, Hershko A, Ben-Chetrit E. (2002). Paroxetine associated hepatotoxicity: a report of 3 cases and a review of the literature. Pharmacopsychiatry. (3 cases of paroxetine hepatotoxicity; case 1 was a 49 year old man who developed rash and fever 18 days after starting paroxetine and trazodone [bilirubin 1.3 rising to 8.6 mg/dL, ALT 975 U/L, Alk P normal], resolving within 4 weeks of stopping; cases 2 and 3 were 80 and 85 year old men who developed abnormal liver tests 2-3 weeks after starting paroxetine [bilirubin normal, ALT 416 and 630 U/L], resolving rapidly upon stopping, but both patients had multiple medical conditions, heart disease, renal failure and sepsis).
Carvajal García-Pando A, García del Pozo J, Sánchez AS, Velasco MA, Rueda de Castro AM, Lucena MI. (2002). Hepatotoxicity associated with the new antidepressants. J Clin Psychiatry. (Analysis of cases of hepatotoxicity from antidepressants in Spanish Pharmacovigilance System from 1989-1999, identified 99 cases; among SSRIs, 26 due to fluoxetine, 14 paroxetine, 6 fluvoxamine, 5 sertraline, 3 venlafaxine and 2 citalopram; among tricyclics, 16 clomipramine 7 amitriptyline, 6 imipramine; among miscellaneous, 3 nefazodone and 1 trazodone; but all similar in rate ~1-3 per 100,000 patient-years of exposure, except for nefazodone=29/100,000).
Lucena MI, Carvajal A, Andrade RJ, Velasco A. (2003). Antidepressant-induced hepatotoxicity. Expert Opin Drug Saf. (Review of hepatotoxicity of antidepressants; antidepressant use has increased markedly between 1992 and 2002, accounting for 5% of cases of hepatotoxicity; SSRIs are less likely to cause injury than tricyclics and MAO inhibitors; range of presentations, typically self-limited and rapid recovery; no hallmarks of hypersensitivity).
Spigset O, Hägg S, Bate A. (2003). Hepatic injury and pancreatitis during treatment with serotonin reuptake inhibitors: data from the World Health Organization (WHO) database of adverse drug reactions. Int Clin Psychopharmacol. (Among 27,542 reports of hepatic injury in WHO database, 786 related to SSRIs [3%], including citalopram 42, fluoxetine 222, fluvoxamine 54, paroxetine 191, sertraline 112, nefazodone 91 and venlafaxine 74; only nefazodone has an excess of hepatic reports in relationship to total reports).
Milkiewicz P, Chilton AP, Hubscher SG, Elias E. (2003). Antidepressant induced cholestasis: hepatocellular redistribution of multidrug resistant protein (MRP2). Gut. (Two cases of cholestasis due to antidepressants; 30 year old woman developed jaundice 8 weeks after starting citalopram [bilirubin 4.4 mg/dL, AST 33 U/L, Alk P 637 U/L], resolving within 2 months of stopping; 63 year old man developed jaundice 3 months after starting the tricyclic dothiepin [bilirubin 9.4 mg/dL, AST 40 U/L, Alk P 600 U/L], resolving within 3 months of stopping with corticosteroid therapy and later tolerating fluoxetine for 12 months, but redeveloping a similar pattern 2 months after starting paroxetine [bilirubin 15.2 mg/dL, AST 36 U/L, Alk P 544 U/L], resolving within 6 months of stopping).
Degner D, Grohmann R, Kropp S, Rüther E, Bender S, Engel RR, Schmidt LG. (2004). Severe adverse drug reactions of antidepressants: results of the German multicenter drug surveillance program AMSP. Pharmacopsychiatry. (Analysis of adverse drug reactions reported from 1993-2000 in 35 psychiatric hospitals; 0.7% of SSRI recipients had a severe adverse event; hepatic in 0.05%).
Colakoglu O, Tankurt E, Unsal B, Ugur F, Kupelioglu A, Buyrac Z, Akpinar Z. (2005). Toxic hepatitis associated with paroxetine. Int J Clin Pract. (62 year old man with renal failure and anti-HCV developed jaundice 3 months after starting paroxetine [bilirubin 47.1 mg/dL, ALT 1321 U/L, Alk P 1321 U/L, eosinophils 6%, protime 18.2 sec, HCV RNA negative], resolving 3 months after stopping).
Guzmán Ruiz O, Ramírez Martín del Campo M, Fernandez López I, Romero Gómez M. (2005). Med Clin (Barc). (32 year old woman with type 1 diabetes developed ketoacidosis and mild enzyme elevations 4 months after starting paroxetine [normal bilirubin and Alk P, ALT 220 U/L], which resolved rapidly upon stopping, and she later tolerated citalopram without recurrence).
Pinzani V, Peyriere H, Hillaire-Buys D, Pageaux GP, Blayac BP, Larrey D. (2006). Specific serotonin recapture inhibitor (SSRI) antidepressants: hepatoxicity assessment in a large cohort in France. J Hepatol. (Abstract: Analysis of French Pharmacovigilance data on SSRIs found 63 cases of hepatotoxicity from paroxetine, 45 fluoxetine, 30 citalopram, 18 sertraline, and 2 fluvoxamine).
Sabaté M, Ibáñez L, Pérez E, Vidal X, Buti M, Xiol X, Mas A, et al. (2007). Risk of acute liver injury associated with the use of drugs: a multicentre population survey. Aliment Pharmacol Ther. (Among 126 cases of drug induced liver injury seen in Spain between 1993-2000, 3 were attributed to paroxetine and 3 to fluoxetine with a relative risk of injury to rate of use in the population of 3.0 and 1.8, respectively).
DeSanty KP, Amabile CM. (2007). Antidepressant-induced liver injury. Ann Pharmacother. (Review of drug induced liver injury and reports of injury from MAO inhibitors, SSRIs, tricyclics and atypical agents).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, 6 were attributed to duloxetine, 3 to atomoxetine, 2 to fluoxetine, 2 to bupropion, and 1 to sertraline as single agents; no cases were attributed to paroxetine).
Marks DM, Park M-H, Ham B-J, Han C, Patkar AA, Masand PS, Pae C-U. (2008). Paroxetine: safety and tolerability issues. Expert Opin Drug Saf. (Review of pharmacology and safety of paroxetine; side effects are similar to those of other SSRIs, discontinuation rates of 9-20%; weight gain averages 3.6% and sexual dysfunction ranges from 22-65%, both of which are higher than with other SSRIs; no discussion of hepatotoxicity).
Pompili M, Tittoto P, Mascianà R, Gasbarrini G, Rapaccini GL. (2008). Acute hepatitis associated with use of paroxetine. Intern Emerg Med. (84 year old woman with atrial fibrillation and cerebrovascular disease presented with confusion and had rises in ALT [13→2110 U/L], Alk P [180→277 U/L], and bilirubin [1.0→2.5 mg/dL], and abnormal INR [2.1] and ammonia [335 µmol/L] within a week of starting paroxetine, resolving within 15 days of stopping).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, one attributed to venlafaxine and one to fluoxetine, but none to paroxetine).
Molleston JP, Fontana RJ, Lopez MJ, Kleiner DE, Gu J, Chalasani N, Drug-induced Liver Injury Network. (2011). Characteristics of idiosyncratic drug-induced liver injury in children: results from the DILIN prospective study. J Pediatr Gastroenterol Nutr. (Among 30 children with suspected drug induced liver injury, half [n=15] were due to antimicrobials [minocycline 4, INH 3, azithromycin 3] and the rest largely due to CNS agents and anticonvulsants; one case was attributed to amitriptyline, but paroxetine and other antidepressants were not listed).
Park SH, Ishino R. (2013). Liver injury associated with antidepressants. Curr Drug Saf. (Review of antidepressant induced liver injury).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, none of which were attributed to paroxetine).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, only one of which was attributed to an antidepressant [amitriptyline] and none to a MAO inhibitor, SSRI or SNRI).
Kato M, Kimura T, Kimura T, Hara T. (2015). Safety and effectiveness of controlled-release paroxetine in routine clinical practice: results of a postmarketing surveillance study of patients with depression. Neuropsychiatr Dis Treat. (Postmarketing surveillance of a controlled release paroxetine in 3213 patients with depression found that nausea [3.5%] and somnolence [2.7%] were the most frequent adverse event and among 22 serious adverse events, none were liver related).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al. (2015). United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 20 cases [2%] were attributed to antidepressants including 9 due to SNRIs [7 to duloxetine, 1 each to nefazodone and trazodone], 5 to bupropion, 5 to SSRIs [3 to escitalopram, and 1 each to fluoxetine and sertraline], and only 1 to tricyclics [imipramine]).
Woo HJ, Kim HY, Choi ES, Cho YH, Kim Y, Lee JH, Jang E. (2015). Drug-induced liver injury: A 2-year retrospective study of 1169 hospitalized patients in a single medical center. Phytomedicine. (Among 1169 inpatients seen at a single Korean referral medical center over a 2 year period, 11 developed suspected drug induced liver injury, 6 attributed to dietary supplements and 5 to conventional drugs including 2 antidepressants [minocycline, donepezil, warfarin, gabapentin/milnacipran, and antihistamines]).
Voican CS, Martin S, Verstuyft C, Corruble E, Perlemuter G, Colle R. (2016). Liver function test abnormalities in depressed patients treated with antidepressants: a real-world systematic observational study in psychiatric settings. PLoS One. (Among 321 psychiatric inpatients, only 116 [36%] had liver tests performed and only 18 during therapy with an antidepressant, 3 of which were suspected to have drug-induced liver injury, 1 each with escitalopram, venlafaxine and amitriptyline, all without jaundice and 2 without symptoms, all 3 resolving).
Friedrich ME, Akimova E, Huf W, Konstantinidis A, Papageorgiou K, Winkler D, Toto S, et al. (2016). Drug-induced liver injury during antidepressant treatment: results of AMSP, a drug surveillance program. Int J Neuropsychopharmacol. (Among 184,234 psychiatric inpatients from 80 hospitals, 149 cases [0.08%] of drug induced liver injury were reported including 22 of 70,060 [0.03%] receiving SSRIs, 71 of 50,201 [0.14%] patients treated with tricyclics and 3 of 3869 receiving MAO inhibitors [0.08%]).
Gahr M, Zeiss R, Lang D, Connemann BJ, Hiemke C, Schönfeldt-Lecuona C. (2016). Drug-Induced liver injury associated with antidepressive psychopharmacotherapy: an explorative assessment based on quantitative signal detection using different MedDRA terms. J Clin Pharmacol. (Using data on adverse drug reaction reports from the Uppsala Monitoring Center of WHO, there were higher relative hepatotoxicity reports for nefazodone, agomelatine, many tricyclics and mirtazapine).
Nicoletti P, Aithal GP, Bjornsson ES, Andrade RJ, Sawle A, Arrese M, Barnhart HX, et al., International Drug-Induced Liver Injury Consortium, Drug-Induced Liver Injury Network Investigators, and International Serious Adverse Events Consortium. (2017). Association of liver Injury from specific drugs, or groups of drugs, with polymorphisms in HLA and other genes in a genome-wide association study. Gastroenterology. (A genome wide association study done on 862 patients with drug-induced liver injury found several associations within the HLA region, most striking was HLA-A*33:01 with an allele frequency of 0.01 in Caucasian controls and 0.02 in patients [0.01 with hepatocellular and 0.04 with cholestatic injury], particularly frequent with injury due to ticlopidine [in 4 of 5 cases], methyldopa [2 or 4], fenofibrate [4 of 7], terbinafine [6 of 14], enalapril [2 or 4], sertraline [2 of 5] and erythromycin [2 of 10]).
Chen VC, Lin CF, Hsieh YH, Liang HY, Huang KY, Chiu WC, Lee Y, McIntyre RS, et al. (2017). Hepatocellular carcinoma and antidepressants: a nationwide population-based study. Oncotarget. (Among almost 50,000 cases of hepatocellular carcinoma registered in the Taiwan National Health Insurance Research Database, the rate of antidepressant use was lower than in approximately 250,000 matched controls from the database).
Kishi T, Matsuda Y, Matsunaga S, Moriwaki M, Otake Y, Akamatsu K, Okochi T, et al. (2017). Escitalopram versus paroxetine controlled release in major depressive disorder: a randomized trial. Neuropsychiatr Dis Treat. (Among 88 patients with major depression treated with escitalopram or paroxetine for 24 weeks, rates of response and of adverse events were similar between the two groups and there were no drug related serious adverse events; no mention of ALT levels or hepatotoxicity).
Gómez-Lumbreras A, Marcos-Fosch C, Aguilera C. (2018). Psychotropic drugs and liver toxicity. Am J Ther. (Case report of a woman who developed abdominal pain and jaundice 4 months after starting both paroxetine and olanzapine [bilirubin 7.3 mg/dL, ALT 984 U/L, Alk P 174 U/L], which resolved after stopping both medications and treatment with prednisone).
Ferrajolo C, Scavone C, Donati M, Bortolami O, Stoppa G, Motola D, Vannacci A, et al., DILI-IT Study Group. (2018). Antidepressant-induced acute liver injury: a case-control study in an Italian inpatient population. Drug Saf. (Among 179 cases of hospitalizations for unexplained acute liver injury enrolled in an Italian prospective study between 2010 and 2014, 17 had been exposed to antidepressants the major implicated agents being citalopram [n=4], sertraline [n=3], paroxetine [n=3], tricyclics [n=2], trazodone [n=1], fluoxetine [n=1], and duloxetine [n=1).
Billioti de Gage S, Collin C, Le-Tri T, Pariente A, Bégaud B, Verdoux H, Dray-Spira R, et al. (2018). Antidepressants and hepatotoxicity: a cohort study among 5 million individuals registered in the French National Health Insurance Database. CNS Drugs. (Among 5 million persons identified in a national French health insurance database who started an antidepressant between 2010 and 2015, 382 developed serious liver injury resulting in hospitalization, rates per 100,0000 persons-years being 19 for SSRIs, 22 venlafaxine, 13 duloxetine, and 33 mirtazapine).
Chan HL, Chiu WC, Chen VC, Huang KY, Wang TN, Lee Y, McIntyre RS, et al. (2018). SSRIs associated with decreased risk of hepatocellular carcinoma: A population-based case-control study. Psychooncology. (Analysis of the Taiwan National Health Service Insurance Research Database identified 59,859 patients with initial diagnosis of hepatocellular carcinoma and 285,124 matched controls; SSRI use was more frequent in the controls than in the HCC cases but only in analyses adjusted for risk factors).
Lochmann D, Richardson T. (2019). Selective serotonin reuptake inhibitors. Handb Exp Pharmacol. (Overview of the SSRIs mentioned that they have similar efficacy in treating depression and similar rates and adverse event profile which largely represents the effects of serotonin excess: nausea, diarrhea, dizziness, somnolence, insomnia, sweating, tremor anxiety, dry mouth, anxiety and restlessness; they can also cause weigh gain and sex dysfunction as well as activate mania and cause withdrawn symptoms).
Pladevall-Vila M, Pottegård A, Schink T, Reutfors J, Morros R, Poblador-Plou B, Timmer A, et al. (2019). Risk of acute liver injury in agomelatine and other antidepressant users in four European countries: a cohort and nested case-control study using automated health data sources. CNS Drugs. (Analysis of data sources from 4 European countries identified 3.2 million persons initiating antidepressant therapy among whom there was no increased risk for acute liver injury for agomelatine compared to citalopram, an SSRI with a low rate of hepatotoxicity).
(2019). Drugs for anxiety disorders. Med Lett Drugs Ther. (Concise review of drugs for anxiety including SSRIs, SNRIs and benzodiazepines including mechanism of action, clinical efficacy, safety and costs; does not mention ALT elevations or hepatotoxicity).
(2020). Drugs for depression. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, safety and costs of drugs for depression; hepatotoxicity is mentioned only for nefazodone [now rarely used because of severe hepatotoxicity] and duloxetine [in heavy drinkers]).
Ueberberg B, Frommberger U, Messer T, Zwanzger P, Kuhn J, Anghelescu I, Ackermann K, Assion HJ. (2020). Drug-induced liver injury (DILI) in patients with depression treated with antidepressants: a retrospective multicenter study. Pharmacopsychiatry. (Among 329 psychiatric inpatients with depression seen at 6 psychiatric centers in Germany, 17 [5%] had serum aminotransferase elevations but none had clinically apparent liver injury, most commonly implicated drugs included mirtazapine, agomelatine, citalopram and venlafaxine).

## OTHER REFERENCE LINKS

1 Recent References on Paroxetine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(paroxetine)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Paroxetine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=paroxetine)